# Sparsentan

## OVERVIEW

### Introduction

Sparsentan is a dual endothelin receptor and angiotensin II receptor antagonist that is used to decrease proteinuria in patients with IgA nephropathy. Sparsentan is associated with a low rate of serum enzyme elevations during therapy but has not been linked to instances of clinically apparent liver injury although it has had only limited clinical experience.

### Background

Sparsentan (spar sen’ tan) is a small molecule antagonist of both the endothelin type A receptor and angiotensin II type 1 receptor. Endothelin is a potent vasoconstrictor produced by endothelial cells that engages receptors on multiple cell types in liver, lung, kidney, brain and other tissues. Angiotensin II is the final step in the renin-angiotensin system, receptors of which are found in arteries and capillaries. Endothelin receptor blockers are used in the therapy of essential arterial hypertension as well as pulmonary hypertension. Angiotensin II receptor blockers (ARBs) are used to treat hypertension. Combined antagonism of both endothelin and angiotensin II receptors was proposed as possible therapy for IgA nephropathy, a kidney disease marked by deposits of immune complexes with abnormal IgA molecules in glomeruli resulting in proteinuria, hypertension, and progressive renal dysfunction. The cause of IgA nephropathy is unknown, but it is believed to be immune mediated and is often treated with immunosuppressive agents, such as prednisone and budesonide. Inhibition of both endothelin and angiotensin II decreases vasoconstriction but also inhibit cell proliferation, matrix synthesis, and proinflammatory signaling, factors that contribute to the glomerular injury in IgA nephropathy. In animal models, sparsentan decreased renal injury and fibrosis. Sparsentan was evaluated in controlled trials in patients with biopsy proven IgA nephropathy and proteinuria. Compared to conventional therapy with irbesartan (an angiotensin II receptor blocker), sparsentan was associated with a greater mean decrease in the urine protein-to-creatinine ratio and an increased rate of resolution of proteinuria. In 1923, sparsentan was given accelerated approval in the United States for use in adults with IgA nephropathy and high risk of progression. It is available in tablets of 200 and 400 mg under the brand name Filspari. The recommended initial dose is 200 mg once daily, with the option to increase to 400 mg daily based upon tolerance and response. Common side effects include peripheral edema, hypotension, headache, dizziness, hyperkalemia and anemia. Sparsentan has embryo-fetal toxicity in animals and should not be used in pregnancy or in women of child-bearing potential not taking a reliable means of birth control. Because of concerns about teratogenicity and hepatic toxicity, sparsentan was initially available only as a part of a REMS program that requires training in monitoring its adverse events as well as documentation and reporting during its use. The REMS requirements regarding teratogenicity, but not hepatotoxicity, were later lifted, but it remains with a boxed warning concerning teratogenicity.

### Hepatotoxicity

In preregistration trials of sparsentan in more than 1000 patients with IgA nephropathy and proteinuria, serum ALT and AST elevations above 3 times the upper limit of normal arose in only 2.5% of treated patients compared to 2.0% of patients treated with an angiotensin II receptor antagonist (irbesartan). The aminotransferase elevations were typically asymptomatic and transient, resolving spontaneously without dose modification or discontinuation. None of the aminotransferase elevations were associated with symptoms or jaundice. Because other endothelin receptor antagonists have been linked to episodes of severe liver injury (bosentan), sparsentan was approved only as a part of a REMS program requiring monitoring of liver tests regularly during therapy (once monthly for the first 12 months and every 3 months thereafter). Since its approval and more wide-spread clinical use, there have been no published cases of liver injury attributed to sparsentan use.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Sparsentan has been linked to serum ALT and AST elevations during therapy but not with clinically apparent liver injury with jaundice. The cause of the aminotransferase elevations is not known but are also common in patients who received other endothelin receptor blockers such as bosentan. Sparsentan is metabolized in the liver by the P450 microsomal enzyme system, predominantly by CYP 3A4 and is susceptible to drug-drug interactions with strong inhibitors or inducers of this enzyme system. Because sparsentan is a substrate for CYP 3A4, it can also compete with the metabolism of other drugs that are metabolized by this enzyme.

Outcome and Management

Sparsentan has been linked to serum ALT and AST elevations during therapy but not with clinically apparent liver injury. Nevertheless, measurements of routine liver tests (ALT, AST and bilirubin) are recommended before starting treatment, monthly during the first year of therapy, and every 3 months thereafter. In the event of ALT or AST elevations above 3 times the upper limit of normal, therapy should be discontinued until values fall to normal or to pre-treatment levels or an alternative cause is identified. In the event of ALT elevations with accompanying jaundice or symptoms or with aminotransferase elevations above 8 times the ULN or with persistent elevations above 5 times the ULN, therapy should be permanently discontinued.

Drug Class: Renal Disease Agents Endothelin Receptor Antagonists

Other members of the subclass: Atrasentan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sparsentan – Filspari®

DRUG CLASS

Renal Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sparsentan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sparsentan | 254740-64-2 | C32-H40-N4-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 06 January 2025

Abbreviations: IgA, immunoglobulin A; ULN, upper limit of the normal range; REMS, Risk Evaluation and Mitigation Strategy; GFR, glomerular filtration rate.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of endothelin receptor inhibitors).
Fraidenburg DR, Desai AA, Yuan JS-J. Treatment of pulmonary arterial hypertension. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 573-84. (Textbook of pharmacology and therapeutics).
Hilal-Dandan R. Renin and angiotensin. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 471-88. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/211801Orig1s003.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; provides the product label that describes the Risk Evaluation and Mitigation Strategy for sparsentan requiring measuring of ALT, AST and total bilirubin levels before and then monthly after starting therapy for one year and every 3 months thereafter with interruption for ALT or AST above 3 times ULN and discontinuation if above 5 times ULN or if bilirubin rises above twice ULN or INR above 1.5).
Wyatt RJ, Julian BA. IgA nephropathy. N Engl J Med. 2013;368:2402-14.. (Review of the clinical features, natural history, diagnosis, pathogenesis and treatment of IgA nephropathy, discusses control of hypertension and proteinuria as the current basis of management). 23782179
Martínez-Díaz I, Martos N, Llorens-Cebrià C, Álvarez FJ, Bedard PW, Vergara A, Jacobs-Cachá C, Soler MJ. Endothelin receptor antagonists in kidney disease. Int J Mol Sci. 2023;24:3427.. (Review of the role of endothelin in the pathogenesis of kidney disease and the pre-clinical and clinical efficacy and safety of endothelin receptor antagonists in preventing or reversing kidney disease mentions the possible role of dual antagonism of angiotensin II and endothelin receptors in IgA nephropathy). 36834836
Heerspink HJL, Radhakrishnan J, Alpers CE, Barratt J, Bieler S, Diva U, Inrig J, et al.; PROTECT Investigators. Sparsentan in patients with IgA nephropathy: a prespecified interim analysis from a randomised, double-blind, active-controlled clinical trial. Lancet. 2023:S0140-6736(23)00569-X. PMID: 37015244. (Among 404 patients with biopsy proven IgA nephropathy at risk for progressive kidney dysfunction with hypertension and proteinuria treated with sparsentan [200 to 400 mg] or irbesartan [300 mg] once daily for at least 36 weeks, the urinary protein to creatinine ratio decreased more with sparsentan [-49% vs -15%] as did the proportion of patients with resolution of proteinuria [21% vs 8%], and adverse events included peripheral edema [24% vs 9%], hypotension [14% vs 6%], hyperkalemia [13% vs 10%], fatigue [7% vs 4%], and cough [5% vs 2%], while ALT or AST elevations above 3 times ULN arose in 2% of both groups and there were no instances of ALT elevations with jaundice or symptoms).
Syed YY. Sparsentan: First Approval. Drugs. 2023;83:563-568.. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of sparsentan shortly after its approval for use in the United States; mentions that US prescribing information includes a boxed warning about hepatotoxicity and that patients should be monitored for this potential risk). 37022667
Kohan DE, Barton M. Endothelin and endothelin antagonists in chronic kidney disease. Kidney Int. 2014 Nov;86(5):896-904. doi: . Epub 2014 May 7.; PMCID: PMC4216619.10.1038/ki.2014.143 (Review of the synthesis, distribution, pharmacology and activity of endothelin and the potential role of its inhibition in treatment of chronic kidney disease). 24805108
Benigni A, Buelli S, Kohan DE. Endothelin-targeted new treatments for proteinuria and inflammatory glomerular diseases: focus on the added value to anti-renin-angiotensin system inhibition. Pediatr Nephrol. 2021;36:763-775.. (Review of the role of endothelin in normal renal physiology as well as in causing progression in chronic renal disease and the effects of endothelin receptor inhibition in improving renal function and decreasing fibrosis in animal models of chronic kidney disease and having antiproteinuric effects in human diseases). 32185491
Rovin BH, Barratt J, Heerspink HJL, Alpers CE, Bieler S, Chae DW, Diva UA, et al.; DUPRO steering committee and PROTECT Investigators. Efficacy and safety of sparsentan versus irbesartan in patients with IgA nephropathy (PROTECT): 2-year results from a randomised, active-controlled, phase 3 trial. Lancet. 2023;402(10417):2077-2090.. (Among 404 adults with IgA nephropathy and proteinuria treated with sparsentan [400 mg] vs irbesartan [300 mg] once daily for up to 110 weeks, sparsentan treated patients had a slower rate of glomerular filtration rate [GFR] decline [-2.7 vs -3.8 mL/min], less renal failure [9% vs 13%], and greater decline in urinary protein-to-creatinine ratio [-43% vs -4%] with similar rates of adverse events [93% vs 88%] and aminotransferase elevations above 3 times ULN [2% vs 3%] and no liver related deaths or serious adverse events). 37931634
Rheault MN, Alpers CE, Barratt J, Bieler S, Canetta P, Chae DW, Coppock G, et al.; DUPRO Steering Committee and DUPLEX Investigators. Sparsentan versus irbesartan in focal segmental glomerulosclerosis. N Engl J Med. 2023;389:2436-2445.. (Among 371 patients with focal segmental glomerulosclerosis [FCGS] treated with sparsentan [800 mg] vs irbesartan [300 mg] daily for 108 weeks, sparsentan treated patients had a greater reduction in proteinuria but only slightly lower decline in GFR, while adverse event rates were similar [overall 94% vs 93%, serious 37% vs 44%], and ALT or AST elevations above 3 times ULN arose in 2.7% vs 2.2%, all of which resolved and none were accompanied by bilirubin elevations). 37921461
Smeijer JD, Kohan DE, Dhaun N, Noronha IL, Liew A, Heerspink HJL. Endothelin receptor antagonists in chronic kidney disease. Nat Rev Nephrol. 2025;21:175-188.. (Extensive review of the role of endothelin receptor antagonists in the treatment of chronic kidney diseases mentions that liver toxicity has been observed with some antagonists, particularly with bosentan, but for most, including atrasentan and sparsentan, liver enzyme elevations have been modest). 39643698
In brief: Embryotoxicity REMS removal for endothelin receptor antagonists. Med Lett Drugs Ther. 2025;67(1737):152. PMID: 40925866. (The Risk Evaluation and Mitigation Strategy [REMS] requirements for embryotoxicity was removed by the FDA for the endothelin receptor antagonists, but the REMS requirement for hepatotoxicity warning and monitoring was maintained for bosentan and sparsentan).
Fan H, Yang Y, Li J, Huang Z, Zhou B. Comprehensive analysis of sparsentan-related adverse events: latest insights from VigiAccess and FAERS. J Nephrol. 2025;38:2881-2891.. (Analysis of the spontaneous reports of adverse events attributed to sparsentan made to the World Health Organization’s drug vigilance registry up to 2024, identified 1746 reports, only 17 [~1%] of which were hepatic enzyme elevations and a similar low rate found in the FDA’s Adverse Event Reporting System [FAES]; no mention of drug-induced liver injury and no specific details provided). 41023522

## OTHER REFERENCE LINKS

1. Recent References on Sparsentan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sparsentan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sparsentan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sparsentan)